# Mifepristone

## OVERVIEW

### Introduction

Mifepristone, also known as RU-486, is a potent synthetic steroidal antiprogesterone which is used as a single dose in combination with misoprostol, a prostaglandin analogue, to induce medical abortion. Mifepristone with misoprostol have not been associated with serum enzyme elevations or with clinically apparent liver injury.

Mifepristone alone, without misoprostol, is also approved as therapy of Cushing syndrome where it is given in a higher dose and for extended periods. Long term higher doses of mifepristone have been linked to a low rate of serum enzyme elevations during therapy and rare instances of clinically apparent liver injury.

### Background

Mifepristone (mif" e pris' tone) is a synthetic antiprogesterone which antagonizes the action of progesterone by competing with its binding to its receptor. The sudden loss of progesterone activity during pregnancy causes a series of intrauterine and cervical changes that result in termination of pregnancy. Misoprostol (mye" soe pros' tol) is a prostaglandin analogue that causes uterine contraction which completes the medical abortion. In multiple large prospective studies, the administration of a single dose of mifepristone followed within 24 to 48 hours by a prostaglandin agonist safely terminated early pregnancy in more than 90% of women. Mifepristone was first approved for use in France in 1988, in Great Britain in 1991, Sweden in 1992, and the United States in 2000. The current indications for this combination is for medical termination of intrauterine pregnancy through 70 days of gestation. Mifepristone is available in tablets of 200 mg under the brand name Mifeprex. The currently recommended dose of mifepristone for inducing a medical abortion is as a single 200 mg tablet followed 24 to 48 hours later by buccal administration of 800 mcg of misoprostol (a prostaglandin agonist). Mifepristone has been used off-label as a means of emergency contraception, but is not approved for that use. Side effects are common, but generally mild-to-moderate in severity and can include uterine bleeding, nausea, vomiting, abdominal cramps, weakness, fever, headache, diarrhea, and dizziness. Rare, but potentially severe adverse events include serious uterine bleeding and serious bacterial infections, failed abortion and need for hospitalization. Contraindications to use of mifepristone/misoprostol include pregnancy beyond 70 days (10 weeks), ectopic pregnancy, presence of an intrauterine device, adrenal failure, porphyria and use of anticoagulants. Because of the serious nature of these side effects, mifepristone/misoprostol is available only through a Risk Evaluation and Mitigation Strategy (REMS) program to certified prescribers.

Mifepristone (without misoprostol) is also approved for use in Cushing syndrome caused by excessive production of glucocorticoids. Mifepristone also has antiglucocorticoid receptor activity and has been found to alleviate hyperglycemia in adults with hypercortisolism and glucose intolerance or diabetes who have failed to respond or are not candidates for surgical therapy. Mifepristone was approved for this indication in 2012 and is available in 300 mg tablets under the brand name Korlym. The recommended dose is 300 mg once daily initially with subsequent increases based upon efficacy and tolerance to a maximum of 1200 mg daily. Adverse events are not uncommon but generally mild and manageable, including nausea, vomiting, anorexia, fatigue, headache, arthralgia, peripheral edema, hypertension, dizziness, and hypokalemia. Severe adverse reactions include termination of pregnancy, adrenal insufficiency, vaginal bleeding, endometrial changes and QTc interval prolongation. Mifepristone is metabolized by CYP 3A4 and 2C8/2C9 and has many drug-drug interactions.

### Hepatotoxicity

In large prelicensure clinical trials, medical abortion with mifepristone/misoprostol was safe and not accompanied by abnormalities in laboratory tests or cases of hepatitis or jaundice. Since its licensure and more widescale use, there have been no published reports of liver injury attributed to mifepristone and misoprostol used to induce medical abortion.

In contrast, long term, higher dose therapy with mifepristone has been associated with an appreciable rate of serum enzyme elevations during treatment and with rare instances of clinically apparent liver injury. In one report, the onset of liver injury arose after 2 to 3 months of treatment and was characterized by marked jaundice and pruritus, with minimal serum aminotransferase and alkaline phosphatase elevations typical of bland cholestasis as occurs with estrogen or anabolic steroid use. Liver biopsy confirmed the finding of bland cholestasis. While jaundice was severe and prolonged, it ultimately resolved without evidence of residual injury.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which mifepristone might cause liver injury is uncertain, but clinical features suggest that it is due to an estrogen- or androgen-like effect. The injury has been associated only with long term use of mifepristone. The single dose administration of mifepristone and misoprostol and their low doses are possible reasons why they are not hepatotoxic. Mifepristone is metabolized by the liver, largely by the cytochrome P450 isozyme CYP 3A4 and plasma levels vary if inducers or inhibitors of CYP 3A are used concurrently.

### Outcome and Management

Severity of liver injury during mifepristone therapy ranges from asymptomatic elevations in serum aminotransferase levels to symptomatic liver injury with jaundice. Women on long term mifepristone therapy who develop symptoms of fatigue, itching or jaundice should be tested for routine liver tests and therapy discontinued if there is evidence of liver injury. Restarting mifepristone after acute liver injury attributed to its use should be avoided.

Drug Class: Obstetrical and Gynecological Agents, Pregnancy Termination Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mifepristone – Korlym®, Mifeprex®

DRUG CLASS

Pregnancy Termination Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mifepristone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Mifepristone | 84371-65-3 | C29-H35-N-O2 | Mifepristone chemical structure
Misoprostol | 59122-46-2 | C22-H38-O5 | Misoprostol chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 March 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of mifepristone).
Chitturi S, Farrell GC. Estrogen receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal agents; does not discuss mifepristone).
Schimmer BP, Parker KL. Contraception and pharmacotherapy of obstetrical and gynecological disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1833-52. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that elevations in serum enzymes during therapy with long term mifepristone were generally mild, transient and associated with higher doses [1200 mg daily] or use of other potentially hepatotoxic medications).
Couzinet B, Le Strat N, Ulmann A, Baulieu EE, Schaison G. Termination of early pregnancy by the progesterone antagonist RU 486 (Mifepristone). N Engl J Med 1986; 315: 1565-70. (Among 100 women with an early, unwanted pregnancy who were treated with 1 of 3 regimens of mifepristone [400 to 800 mg total dose], 85 had a complete abortion within 8 days and “the only important side effect observed…was prolonged uterine bleeding”). 3785321
Rodger MW, Baird DT. Induction of therapeutic abortion in early pregnancy with mifepristone in combination with prostaglandin pessary. Lancet 1987; 2 (8573): 1415-8. (Among 100 women requesting abortion early in pregnancy who were given oral mifepristone [400-600 mg] followed in 48 hours by a prostaglandin analog [gemeprost] by vaginal pessary, 95 had a complete abortion and adverse events included bleeding, diarrhea, pelvic pain [after prostaglandin], and incomplete abortion requiring surgical evacuation: “liver function tests” were similar before and after therapy). 2891991
Silvestre L, Dubois C, Renault M, Rezvani Y, Baulieu EE, Ulmann A. Voluntary interruption of pregnancy with mifepristone (RU 486) and a prostaglandin analogue. A large-scale French experience. N Engl J Med 1990; 322: 645-8. (Among 2040 women given mifepristone followed in 36-48 hours by a prostaglandin analogue [gemeprost pessary or sulprostone intramuscularly], 96% had a complete medical abortion and adverse events included bleeding in almost all women for 1-33 days but not requiring transfusion, abdominal pain in 70-80% with 5-23% requiring analgesics, nausea and diarrhea; no mention of ALT elevations or hepatotoxicity). 2304490
Mifepristone (RU 486). Med Lett Drugs Ther 1990; 32 (833): 112-3. (Concise review of the mechanism of action, efficacy, and safety of oral mifepristone for induction of medical abortion). 2247020
Peyron R, Aubény E, Targosz V, Silvestre L, Renault M, Elkik F, Leclerc P, et al. Early termination of pregnancy with mifepristone (RU 486) and the orally active prostaglandin misoprostol. N Engl J Med 1993; 328: 1509-13. (Among 873 women in two open label trials of mifepristone and different doses of misoprostol 48 hours later, medical abortion was induced in 96-98% and adverse events included uterine bleeding and cramps, nausea and diarrhea; no mention of ALT elevations or hepatotoxicity). 8479487
Cheng L, Che Y, Gülmezoglu AM. Interventions for emergency contraception. Cochrane Database Syst Rev 2012; (8): CD001324. (Systematic analysis of 100 randomized controlled trials of emergency contraception with 55,666 women using mifepristone, levonorgestrel, copper intrauterine device placement and ulipristal reported that all regimens were safe; no mention of ALT elevations or hepatotoxicity). 22895920
Mifepristone for Cushing's syndrome. Med Lett Drugs Ther 2012; 54 (1392): 46-7. (Concise review of the mechanism of action, clinical efficacy, safety and costs of mifepristone for Cushing syndrome shortly after its approval for this indication in the US; does not mention ALT elevations or hepatotoxicity). 22683927
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury collected in the United States between 2004 and 2012, no cases were attributed to mifepristone or other emergency contraception regimens). 25754159
Mifepristone (Mifeprex) label changes. Med Lett Drugs Ther 2016; 58 (1493): 55-6. (Concise summary of changes in dosages of mifepristone [200 mg] and misoprostol [800 mcg] and expansion of indications [use within 70 days after first day of last menstrual period]). 27101211
Kapur A, Angomchanu R, Dey M. Efficacy of use of long-term, low-dose mifepristone for the treatment of fibroids. J Obstet Gynaecol India 2016; 66 (Suppl 1): 494-8. (Among 36 women with uterine fibroids treated with low dose mifepristone [50 mg once weekly] for 24 weeks, fibroid volume, menorrhagia and pelvic pain improved but there was a transient rise in "mean transaminases [AST/ALT] at 6 months", which resolved within 3 months of stopping; details not provided). 27651652
Ragucci E, Nguyen D, Lamerson M, Moraitis AG. Effects of mifepristone on nonalcoholic fatty liver disease in a patient with a cortisol-secreting adrenal adenoma. Case Rep Endocrinol 2017; 2017: 6161348. (A 49 year old woman with nonalcoholic steatohepatitis and Cushing syndrome treated with mifepristone [900 mg daily] for 24 weeks had a 16 pound weight loss and marked improvement in serum ALT levels [232 U/L to ~40 U/L], which remained normal after stopping). 29348947
Funke K, Rockey DC. Cholestatic drug-induced liver injury caused by mifepristone. Hepatology 2018 Dec 18. [ePub ahead of print] (65 year old woman with Cushing syndrome developed jaundice 3 months after starting mifepristone [300 mg rising to 900 mg daily] with initial bilirubin rising from 17 to a peak of 33 mg/dL, ALT 49 to 169 U/L and Alk P 80 to 170 U/L, and liver biopsy showing bland cholestasis; jaundice persisting for 3 months but ultimately resolving; injury resembling anabolic steroid or estrogen associated cholestatic jaundice). 30561784

## OTHER REFERENCE LINKS

1. Recent References on Mifepristone/Misoprostol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mifepristone/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Mifepristone/Misoprostol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mifepristone)